# Thyroid Hormone

## OVERVIEW

### Introduction

Thyroid hormones used therapeutically include crude thyroid extracts as well as synthetic forms of L-thyroxine (levothyroxine, T4) and L-triiodothyronine (liothyronine, T3). Thyroid hormone plays an essential role in growth and development and regulates multiple metabolic processes that are responsible for functional homeostasis. When given in high doses, thyroid hormone preparations can cause mild serum enzyme elevations. In addition, standard doses of levothyroxine have been linked to rare instances of mild, immunoallergic liver injury.

### Background

Levothyroxine (lee" voe thye rox' een) is an orally available form of T4 that is commonly used to treat hypothyroidism and maintain the euthyroid state. Other forms of thyroid hormone include thyroid extract and triiodothyronine (T3) or liothyronine (lye" oh thye' roe neen). Thyroid hormone is essential for normal growth, particularly of the central nervous system. In adults, thyroid hormone maintains normal metabolism in virtually all organ systems. Thyroxine (T4) is released from the thyroid gland, but is converted in the liver and other tissues to the active form, which is triiodothyronine (T3) which engages thyroid hormone receptors in the nucleus of cells, which together bind to DNA, leading to transcription of thyroid responsive genes that have multiple actions in different cells affecting cell metabolism. Thyroid hormone is necessary for normal growth and development, and deficiency of thyroid hormone results in cretinism in children and hypothyroidism and myxedema in adults with a multitude of symptoms, signs and laboratory abnormalities, including fatigue, weight gain, drowsiness, mental torpor and confusion. Hypothyroidism is readily treated with oral forms of thyroid hormone which have been in clinical use for over 50 years, the most commonly used being desiccated thyroid (Armour Thyroid, 1950s), synthetic L-thyroxine or levothyroxine (T4, Synthroid, Levoxyl and others: 2002), and L-triiodothyronine or liothyronine (T3, Cytomel: 1956). Levothyroxine is currently one of the most commonly prescribed medications in the United States, with more than 100 million prescriptions filled yearly. The current indications are for maintenance of the euthyroid state. Levothyroxine is available in tablets at of 25 to 300 mcg for oral administration and as a lyophilized powder for parenteral use. Levothyroxine is typically started at a low daily dose (25 to 50 mcg) and increased based upon clinical effect and serum levels of thyroid stimulating hormone (TSH) and free T4. The usual adult replacement dose is 75 to 125 mcg daily. Side effects are uncommon at correct replacement doses, but high doses can cause symptoms of hyperthyroidism such as fatigue, weight loss, headache, anxiety, tremor, muscle weakness, tachycardia, cardiac arrhythmias, menstrual abnormalities, irritability, emotional labiality, sleep disturbance and changes in personality.

### Hepatotoxicity

There is little information on serum aminotransferase levels during thyroxine therapy, but it is a very commonly prescribed medication and, at conventional doses, has not been linked to serum enzyme elevations. High doses of levothyroxine and other thyroid preparations, however, can cause serum enzyme elevations, typically in a hepatocellular or mixed pattern. Indeed, spontaneous hyperthyroidism can be accompanied by serum enzyme elevations and even jaundice. Minor serum enzyme elevations may also accompany hypothyroidism or Hashimoto disease. The liver test abnormalities accompanying hyper- or hypo-thyroidism generally resolve promptly with establishment of the euthyroid state.

High doses of thyroxine and hyperthyroidism also may exacerbate underlying liver disease including drug-induced liver injury, as has been described with acetaminophen and halothane hepatotoxicity. Overdose of thyroxine, however, does not usually cause liver injury. Thyroid hormones also can have multiple drug-drug interactions and other drugs can cause changes in thyroid status, such as hypothyroidism.

Finally, there have been rare reports of immunoallergic hepatitis or hypersensitivity reactions due to levothyroxine which was associated with enzyme elevations and even mild jaundice. The time to onset ranged from 1 to 8 weeks and symptoms typically included fever and fatigue. The enzyme pattern was usually hepatocellular or mixed. Autoantibodies were not detected, but eosinophilia was common. The fever resolved rapidly upon stopping the thyroid preparation, but liver test abnormalities generally required one to two months to fall into the normal range. In at least one case, switching to another form of thyroid hormone was associated with persistence of fever and a worsening of liver tests. In contrast, waiting until recovery from the liver injury and starting triiodothyronine at a low dose with gradual increase to therapeutic levels was generally tolerated without recurrence. Strikingly, the case reports of liver injury due to levothyroxine and thyroid extract were all reported from Asia and Japan, which suggests a racial and possibly genetic predisposition to this idiosyncratic hypersensitivity reaction. Another possibility, however, was that the cases were due to a locally contaminated commercial preparation of levothyroxine.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations and jaundice during levothyroxine induced liver injury is likely due to hypersensitivity and is possibly genetically determined.

### Outcome and Management

Cases of liver injury attributed to levothyroxine and thyroid extract have been mild-to-moderate in severity and self-limited in course, resolving within one to three months of stopping therapy. Rechallenge with levothyroxine has been reported to result in recurrence of fever and hepatic injury, but in several instances patients have later tolerated liothyronine (T3) as a means of treating the hypothyroidism. There have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to levothyroxine therapy.

Drug Class: Thyroid Agents

## CASE REPORT

### Case 1. Immunoallergic hepatitis due to levothyroxine.

[Modified from: Ohmori M, Harada K, Tsuruoka S, Sugimoto K, Kobayashi E, Fujimura A. Levothyroxine-induced liver dysfunction in a primary hypothyroid patient. Endocr J 1999; 46: 579-83. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10580751)].

A 13 year old girl was found to have hypothyroidism thought to be due to Hashimoto thyroiditis with serum TSH levels of 770 µU/mL, free T4 <0.1 ng/dL, thyroid peroxidase antibody 7.9 U/mL, and thyroglobulin antibody 11.8 U/mL. Her serum aminotransferase levels were mildly elevated (ALT 41 U/L, AST 35 U/L, Alk P 176 U/L) and an abdominal ultrasound showed mild fatty liver. She was started on oral levothyroxine in a dose of 50 µg daily which was increased to 150 µg daily. Thyroid test results improved, but she developed fever and mild serum enzyme elevations 3 weeks after starting levothyroxine (Table). The fever persisted despite a decrease in the dose of levothyroxine to 50 mcg daily and she developed fatigue and worsening liver test abnormalities, serum ALT rising to 365 U/L and Alk P to 833 U/L (Table). She had no history of liver disease or risk factors for viral hepatitis and was taking no other medications. Levothyroxine was stopped and her fever resolved within a few days and serum aminotransferase levels began to fall. Four weeks later, she was asymptomatic and liver tests were normal. Because thyroid test abnormalities had returned, low doses of triiodothyronine were started (5 µg daily). Liver tests remained normal and the dose was gradually increased to 50 µg daily.

#### Key Points

Medication: | Levothyroxine (150 µg daily)
Pattern: | Mixed (R=4.7)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 3 weeks
Recovery: | 1 month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | 41 | 176 | 0.4 | Hypothyroidism
1 week | 0 | 30 | | | TSH 820
1 weeks | 50 µg | 42 | | | TSH 81
3 weeks | 150 µg | 41 | 207 | | Fever, TSH 1.9
7 weeks | 50 µg | 365 | 629 | 0.5 | Levothyroxine stopped
9 weeks | 0 | 61 | 833 | | TSH 100
14 weeks | 0 | 28 | 566 | | Liothyronine started
17 weeks | 0 | 21 | 553 | | TSH 6.7
Normal Values | | <31 | <285 | <1.2

#### Comment

Although widely used, levothyroxine has not been mentioned as a cause of drug induced liver injury in large case series. Nevertheless, at least four cases of liver injury attributable to levothyroxine have been reported from Japan. As in the current case, the time to onset was generally within a few weeks of starting, and the presenting symptoms were fever and fatigue. Liver test abnormalities were mild, but transient jaundice occurred in at least two cases (one during rechallenge). Restarting thyroid replacement with triiodothyronine was generally tolerated, but abrupt switching to other forms of thyroid replacement did not always lead to resolution. The cause of the liver injury is unknown, but is likely to be part of a generalized hypersensitivity reaction. The clinical presentation, however, has been characterized as fever and eosinophilia and rarely drug rash.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levothyroxine – Synthroid®

DRUG CLASS

Thyroid Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tetracyclines)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Levothyroxine | 51-48-9 | C15-H11-I4-N-O4 | Levothyroxine chemical structure
Liothyronine | 6893-02-3 | C15-H12-I3-N-O4 | Liothyronine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Review of hepatotoxicity published in 1999; thyroid hormone is mentioned as potentially worsening liver injury due to acetaminophen and halothane, but liver injury due to thyroid hormone alone is not discussed).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 605-620. (Textbook on hepatotoxicity; antithyroid medications are discussed, but not thyroid hormones).
Brent GA, Koenig RJ. Thyroid and anti-thyroid drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 787-802. (Textbook of pharmacology and therapeutics).
Inui A, Ishikawa K, Mizuno N, Oimomi M, Baba S. [Case of Hashimoto's disease with thyroxine induced allergic hepatitis]. Nihon Naika Gakkai Zasshi 1983; 72: 1407-13. Japanese. (63 year old Japanese woman developed fever and fatigue 2 weeks after starting L-thyroxine [bilirubin normal, ALT 2097 U/L, Alk P ~225 U/L, eosinophilia], resolving rapidly on stopping and recurring with restarting L-thyroxine [bilirubin 6.5 mg/dL, ALT ~1000 U/L, Alk P ~200 U/L with rash and fever], but not after subsequent use of triiodothyronine). 6689558
Shibata H, Hayakawa H, Hirukawa M, Tadokoro K, Ogata E. Hypersensitivity caused by synthetic thyroid hormones in a hypothyroid patient with Hashimoto's thyroiditis. Arch Intern Med 1986; 146: 1624-5. (63 year old Japanese woman with hypothyroidism developed fatigue 4 months after starting triiodothyronine [T3] [ALT 1044 U/L, bilirubin and Alk P not given], resolving within 1 month of stopping and recurring with fever within 4 days of starting levothyroxine [bilirubin 1.1 mg/dL, ALT 610 U/L, Alk P 717 U/L, 9% eosinophils], fever resolving in 1 day and liver tests in 2 months; she later tolerated slow introduction of triiodothronine). 3755319
Mandel SH, Magnusson AR, Burton BT, Swanson JR, LaFranchi SH. Massive levothyroxine ingestion. Conservative management. Clin Pediatr (Phila) 1989; 28: 374-6. (29 month old girl ingested 90 levothyroxine tablets [200 µg each] and had high serum T4 levels, but only mild irritability, vomiting and tremor starting around day 4 and resolving within 2 weeks; no mention of ALT elevations or hepatotoxicity). 2758719
Mandel SJ, Brent GA, Larsen PR. Levothyroxine therapy in patients with thyroid disease. Ann Intern Med 1993; 119: 492-502. (Review of the mechanism of action, clinical efficacy, use and safety of levothyroxine; no mention of hepatotoxicity). 8357116
Ohmori M, Harada K, Tsuruoka S, Sugimoto K, Kobayashi E, Fujimura A. Levothyroxine-induced liver dysfunction in a primary hypothyroid patient. Endocr J 1999; 46: 579-83. (13 year old Japanese female with hypothyroidism developed fever and malaise within 3 weeks and rising ALT levels within 6 weeks of starting levothyroxine [bilirubin 0.4 mg/dL, ALT 41 rising to 365 U/L, Alk P 207 rising to 853 U/L], fever resolving within days and liver tests within 2 months of stopping, and not recurring with triiodothyronine: Case 1). 10580751
Kawakami T, Tanaka A, Negoro S, Morisawa Y, Mikami M, Hojo M, Yamamoto T, et al. Liver injury induced by levothyroxine in a patient with primary hypothyroidism. Intern Med 2007; 46: 1105-8. (63 year old Japanese man with hypothyroidism developed liver test abnormalities 2 months after starting levothyroxine [bilirubin 1.5 rising to 11.5 mg/dL, ALT 884 U/L, Alk P 458 U/L], not improving on switching to thyroid extract or triiodothyronine, but resolving when all thyroid was stopped, later tolerating triiodothyronine). 17634708
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to thyroid hormone). 18798340
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to thyroid hormone). 20949552
Warner JV, Morton AP, Hall AJ, Henman MG, Pool LF. Internet slimming, thyrotoxicosis and the liver. Med J Aust 2014; 200: 419-20. (34 year old woman developed thyrotoxicosis and mild serum enzyme elevations 8 weeks after starting a Chinese herbal preparation for weight loss [bilirubin not given, ALT 49 U/L, Alk P 121 U/L], improving but with persistence of liver enzyme abnormalities once the herbal preparation [which was shown to contain free thyroxine] was stopped). 24794677
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to thyroid hormone or levothyroxine). 25754159
Kang S, Amino N, Kudo T, Nishihara E, Ito M, Hirokawa M, Miyauchi A, et al. Occurrence of thyroxine tablet (Thyradin S(®)) - induced liver dysfunction in a patient with subclinical hypothyroidism. Endocr J 2015; 62: 719-24. (54 year old Japanese woman with hypothyroidism developed liver test abnormalities 5 months after starting levothyroxine [bilirubin 0.4 mg/dL, ALT 233 rising to 369 U/L, Alk P 395 U/L], resolving when switched to a powdered form of thyroid hormone, suggesting a contaminant in the thyroxine tablet). 25994001
Li C, Tan J, Zhang G, Meng Z, Wang R, Li W, Zheng W. Risk factors of hyperthyroidism with hepatic function injury: a 4-year retrospective study. Horm Metab Res 2015; 47: 209-13. (Among 1070 patients with new onset Graves disease evaluated at a single, Chinese referral center, liver tests were abnormal in 709 [66%], those with abnormalities tending to be older and having more severe hyperthyroidism). 24867136
Kim CW, Park JS, Oh SH, Park JH, Shim HI, Yoon JW, Park JS, et al. Drug-induced liver injury caused by iodine-131. Clin Mol Hepatol 2016; 22: 272-5. (47 year old woman with thyroid cancer developed a mild episode of hepatitis 10 days after receiving iodine-131 [bilirubin 2.0 mg/dL, ALT 1632 U/L, Alk P 713 U/L, TSH 23.6 mIU/L], responding to corticosteroid therapy and ultimately resolving). 27209646
Wang R, Tan J, Zhang G, Zheng W, Li C. Risk factors of hepatic dysfunction in patients with Graves' hyperthyroidism and the efficacy of 131 iodine treatment. Medicine (Baltimore) 2017; 96: e6035. (Among 2385 patients with new onset Graves disease, 65% had at least one abnormal liver test [details not provided], which usually improved with successful radioactive iodine therapy [Li 2015]). 28151911
Duong N, Lee A, Lewis J. Case of acute mixed liver injury due to hypothyroidism. BMJ Case Rep 2018; 2018: bcr-2017-222373. (77 year old woman with hypothyroidism had elevated liver tests [bilirubin 0.4 mg/dL, ALT 264 U/L, Alk P 211 U/L] that improved with levothyroxine replacement therapy [ALT 37 U/L]). 29367365

## OTHER REFERENCE LINKS

1. Recent References on Thyroid Hormone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Thyroid+Hormone/AE)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Thyroid Hormone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thyroid%20Hormone)